# Amphotericin B

## OVERVIEW

### Introduction

Amphotericin B is an antifungal agent with a broad spectrum of activity against many fungal species. Amphotericin B commonly causes mild to moderate serum aminotransferase elevations and can cause hyperbilirubinemia, but acute, clinically apparent drug induced liver injury from amphotericin B therapy is exceedingly rare.

### Background

Amphotericin (am" foe ter' i sin) B is a polyene macrolide antibiotic that acts by binding to sterols in the plasma membranes of fungi causing the cells to leak, eventually leading to fungal cell death. Amphotericin B is indicated for the treatment of a several fungal and other infections including leishmaniasis, invasive aspergillosis, blastomycosis, candidiasis, coccidiomycosis, cryptococcal meningitis, cryptococcosis, histoplasmosis, mucormycosis, sporotrichosis, and others. Amphotericin B was approved by the FDA in 1971 and is currently widely used in the treatment of serious fungal infections. Amphotericin B is insoluble in water and is formulated for intravenous use by complexing it with lipotrophic molecules such as deoxycholate, liposomes or lipid complexes. Amphotericin is available in multiple forms and concentrations generically and under the brand names Amphocin and Fungizone (deoxycholate), Ambisome (liposome), Abelcet (lipid complex), and Amphotec (cholesteryl sulfate complex). The recommended dose varies by drug form and by disease entity; amphotericin B is given intravenously and the usually dosage is up 0.5 to 1.0 mg/kg daily. Many fungal infections require prolonged therapy (for 1 month to as many as 9 months). Common side effects include fever and chills, nausea, weight loss, headache, malaise, azotemia, hypokalemia, anemia, renal tubular acidosis and phlebitis at peripheral vein infusion sites.

### Hepatotoxicity

Mild and transient elevations in liver enzymes occur in up to 20% of patients receiving amphotericin. Clinically apparent hepatotoxicity is rare, but several convincing cases have been published. The liver injury arises as early as 4 to 14 days after starting therapy, typically with a hepatocellular or mixed pattern of enzyme elevation. Most patients have no symptoms or jaundice. Recovery occurs promptly upon stopping therapy. In addition, isolated but dramatic instances of hyperbilirubinemia arising within days of starting amphotericin have been reported with elevations largely in the direct (conjugated) bilirubin fraction. These patients become visually jaundiced but have no constitutional symptoms, minimal if any elevations in serum ALT or alkaline phosphatase levels, and no evidence of frank hepatic injury. Finally, rare instances of acute cholestatic hepatitis with jaundice have been reported in patients receiving amphotericin, but these patients have generally been critically ill and exposed to multiple potentially hepatotoxic agents, so that the attribution to amphotericin has been weak.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations during amphotericin B therapy is unknown, but may be a direct hepatotoxicity from the polyene based upon its effects on cell membranes. There is little evidence of hypersensitivity, although the injury is idiosyncratic and usually recurs with reexposure and, thus, may be due to a genetic predisposition based upon the metabolism of amphotericin B which is largely hepatic. The hyperbilirubinemia of amphotericin therapy is likely due to inhibition of bilirubin transport mechanisms and is likely to occur in patients with genetic variations in the major hepatic bilirubin transporter (MRP2).

### Outcome and Management

The severity of the liver injury due to amphotericin is usually mild, most patients being asymptomatic and anicteric. Recovery is rapid with stopping amphotericin but can recur with rechallenge. No instances of acute liver failure or chronic liver injury have been convincingly linked to amphotericin therapy. There appears to be no cross sensitivity of the hepatotoxicity of amphotericin to other antifungal agents.

Drug Class: Antifungal Agents

## CASE REPORT

### Case 1. Serum aminotransferase elevations during amphotericin B therapy.

[Modified from: Gill J, Sprenger H, Ralph E, Sharpe M. Hepatotoxicity possibly caused by amphotericin B. Ann Pharmacother 1999; 33: 683-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10410179)]

A 26 year old man developed elevations in serum aminotransferase levels 3 days after starting intravenous amphotericin B for pulmonary blastomycosis. He had received oral itraconazole for 7 days without much improvement before starting amphotericin B. When serum enzymes continued to rise (Table), amphotericin B was stopped while itraconazole was maintained. He was asymptomatic of liver disease, and tests for viral hepatitis and autoantibodies were negative. An abdominal ultrasound showed no evidence of biliary obstruction. A percutaneous liver biopsy showed mild focal fatty change and little evidence of inflammation or hepatocellular necrosis. Stains for fungal elements were negative. Within 4 days of stopping amphotericin B, serum enzymes had returned to baseline.

#### Key Points

Medication: | Amphotericin B (50 mg iv daily; total dose: 225 mg)
Pattern: | Hepatocellular (R=8.2)
Severity: | 1+ (no jaundice)
Latency: | 3 days
Recovery: | 4 days
Other medications: | Itraconazole, lorazepam, ranitidine, docusate sodium, propofol, subcutaneous heparin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
1 day | - | 70 | 128 | - | Also on itraconazole
3 days | - | 266 | 160 | 0.6
4 days | - | 518 | 205 | 0.7
Amphotericin B discontinued
5 days | 0 | 323 | 169 | 0.6 | Liver biopsy
6 days | 1 day | 186 | 140 | 0.7
9 days | 4 days | 69 | 114 | 0.5
Normal Values | | <40 | <130 | <1.2

#### Comment

The evidence that amphotericin was the cause of the liver test abnormalities was the timing of onset within a few days of starting amphotericin B, and the timing of recovery which was immediate upon stopping. The injury was mild and the decision to stop treatment was based entirely on the fact that the serum ALT level had risen to more than 10 times the upper limit of the normal range. While itraconazole was another possible cause of the abnormalities, the serum enzymes decreased immediately upon stopping amphotericin despite continuing itraconazole.

### Case 2. Cholestatic serum enzyme elevations induced by Amphotericin B.

[Modified from: Mohan U, Bush A. Amphotericin B-induced hepatorenal failure in cystic fibrosis. Ped Pulmonol 2002; 33: 497-500. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12001285)]

A nine year old girl with cystic fibrosis developed nausea and vomiting on the third day of amphotericin B therapy for suspected pulmonary aspergillosis. Her symptoms worsened and the amphotericin was switched to a liposomal formulation. Serum enzymes, which had been normal, were found to be elevated by day 8 of therapy. Because of severe vomiting, dehydration and hematemesis, all antibiotic and antifungal therapy was stopped. There were moderate elevations in ALT and alkaline phosphatase levels, but serum bilirubin remained normal. All abnormalities resolved within 7 days of stopping amphotericin.

#### Key Points

Medication: | Amphotericin B (250 µg/kg/day, increased by 250 µg/kg/day; maximum 1 mg/kg/day; total dose: 168 mg)
Pattern: | Cholestatic (R=0.9)
Severity: | 1+
Latency: | 8 days
Recovery: | 7 days
Other medications: | Nebulized colistin, amoxicillin-clavulanic acid, multivitamins, pancreatin, ceftazidime, gentamicin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
5 days | - | 12 | 326 | 0.6
8 days | - | 129 | 464 | 0.4
12 days | - | 364 | 1254 | 0.5
Amphotericin B discontinued
14 days | 2 days | 274 | 722 | 0.7
16 days | 4 days | 72 | 522 | 0.6
19 days | 7 days | 55 | 286 | 0.5
3 weeks | 8 days | 43 | 259 | 0.4
4 weeks | 2 weeks | 32 | 299 | 0.4
Normal Values | | <40 | <130 | <1.2

#### Comment

While the authors described this case as demonstrating hepatorenal failure, most evidence suggests that the hepatic injury was mild. There was no jaundice and laboratory tests returned to baseline rapidly with the patient’s clinical improvement. The elevations in prothrombin time may have been due to the antibiotic therapy and the nutritional status of the patient, rather than hepatic failure. This case demonstrates the difficulty of attributing hepatic enzyme elevations and liver damage to a medication in a critically ill patient with multiple medical problems who is receiving several potent medications, several of which can also cause hepatic injury (clavulanic acid, ceftazidime).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amphotericin B – Generic, Amphocin®, Fungizone®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=amphotericin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Amphotericin B | 1397-89-3 | C47-H73-N-O17 | Image of Amphotericin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2016

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999; “Amphotericin B has rarely been incriminated in hepatic injury”; “The rarity of cases despite widespread use of the drug demonstrates its minimal hepatotoxic threat”).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 470-3. (Review of hepatotoxicity of antifungal agents mentions that amphotericin B rarely causes clinically apparent liver injury but several case reports have been published).
Bennett JE. Antimicrobial agents: antifungal agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-92. (Textbook of pharmacology and therapeutics : amphotericin B is insoluble in water and is formulated for iv use by complexing with bile salts or lipids; binds ergosterol in fungal membrane and increases permeability).
Carnecchia B, Kurtzke J. Fatal toxic reaction to amphotericin B in cryptococcal meningo-encephalitis. Ann Intern Med 1960; 53: 1027-36. (32 year old man with cryptococcal meningitis and complicated course developed nausea and low grade fever with renal insufficiency and severe phlebitis with each of 4 courses of iv amphotericin [60 to 80 mg/day] developing high fever, large tender liver and pneumonia [bilirubin 1.4 mg/dL, Alk P normal], autopsy showing centrolobular fat, but no inflammation and “some degree of hepatic failure”). 13690877
Miller M. Reversible hepatotoxicity related to amphotericin B. Can Med Assoc J 1984; 131: 1245-7. (51 year old man with acute leukemia developed abnormal ALT [950 U/L], Alk P [150 U/L] and bilirubin [1.6 mg/dL] levels 18 days after starting amphotericin B for pulmonary aspergillosis; asymptomatic and improved on stopping with rapid increase in ALT [100→300 U/L] after 2 day rechallenge). 6594184
Abajo FJ, Carcas AJ. Amphotericin B hepatotoxicity. Br Med J 1986; 293: 1243. Not in PubMed (29 year old man with HIV infection developed rising Alk P [1000 U/L] and GGT [133 U/L, normal <65] after 10 days of amphotericin B, with improvement on lowering dose; no symptoms and no mention of ALT).
Stamm AM, Diasio RB, Dismukes WE, Cloud GA, Bowles CA, Karam GH, Espinel-Ingroff A. National Institute of Allergy and Infectious Diseases Mycoses Study Group. Toxicity of amphotericin B plus flucytosine in 194 patients with cryptococcal meningitis. Am J Med 1987; 83: 236-42. (Controlled trial of 4 vs 6 weeks of amphotericin B and flucytosine in 194 patients with cryptococcal meningitis; elevated liver enzymes arose during first 4 weeks in 13 [6.2%] patients, and one patient developed signs and symptoms of hepatitis, dying of acute liver failure 1 month later; authors attributed liver injury to flucytosine). 3303926
Ritchie D. Comment: consideration of amphotericin B hepatotoxicity. DCIP 1991; 25: 559-60. (Author agrees that the case described by Gradon [1991] was likely due to ketoconazole, but stresses that amphotericin B can also cause liver injury). 2068844
Campo C, Antón E, Morata C, Lacruz J. [Amphotericin B associated with severe liver toxicity]. Rev Clin Esp 1999; 199: 49. (36 year old man with HIV infection and esophageal candidiasis developed nausea and confusion during high dose amphotericin B infusions, with ALT rising within 24 hours to 3145 U/L, bilirubin 1.1 mg/dL, LDH 3,223 U/L, rapid recovery within days). 10089782
Walsh TJ, Finberg RW, Arndt C, Hiemenz J, Schwartz C, Bodensteiner D, Pappas P, et al. National Institute of Allergy and Infectious Diseases Mycoses Study Group. Liposomal amphotericin B for empirical therapy in patients with persistent fever and neutropenia. N Engl J Med 1999; 340: 764-71. (Trial of two forms of amphotericin in 687 patients with fever and neutropenia, similar efficacy; side effects were less with liposomal forms; ALT or AST >5 x ULN in 17.8% vs 20.3% with standard amphotericin). 10072411
Cook G, Franklin IM. Adverse drug reactions associated with the administration of amphotericin B lipid complex (Abelcet). Bone Marrow Transplant 1999; 23: 1325-6. (Among 32 patients treated with amphotericin lipid complex, only 2 developed liver test elevations; neither required discontinuation). 10414925
Gill J, Sprenger H, Ralph E, Sharpe M. Hepatotoxicity possibly caused by amphotericin B. Ann Pharmacother 1999; 33: 683-5. (26 year old man with blastomycosis developed elevations in ALT [518 U/L], Alk P [205 U/L] but not bilirubin [0.8 mg/dL] after 10 days of amphotericin B; liver biopsy showed mild fatty change only; enzyme elevations fell to normal within a few days of stopping amphotericin despite continuing itraconazole: Case 1). 10410179
Persat F, Schwartzbrod PE, Troncy J, Timour Q, Maul A, Piens A, Picot S. Abnormalities in liver enzymes during simultaneous therapy with itraconazole and amphotericin B in leukaemic patients. J Antimicrob Chemother 2000; 45: 928-9. (Experience in treating 20 patients with itraconazole [12 also on amphotericin] for 44-495 days, ALT elevations in 11 of 12 who received combination therapy, levels 2-10 times ULNl, all resolving, some with stopping amphotericin alone). 10837458
Fleming RV, Kantarjian HM, Husni R, Rolston K, Lim J, Raad I, Pierce S, et al. Comparison of amphotericin B lipid complex (ABLC) vs. ambisome in the treatment of suspected or documented fungal infections in patients with leukemia. Leuk Lymphoma 2001; 40: 511-20. (Comparison of two formulations of amphotericin B in 75 patients with leukemia and suspected invasive fungal infection; elevations in serum bilirubin above 1.5 mg/dL occurred in 24% but not clinically important; no cases of acute liver injury). 11426524
Ellis M, Shamoon A, Gorka W, Zwaan F, al-Ramadi B. Severe hepatic injury associated with lipid formulations of amphotericin B. Clin Infect Dis 2001; 32: E87-9. (14 year old girl with leukemia developed abdominal pain and jaundice 21 days after completing a 10 day course of amphotericin [bilirubin 12.7 mg/dL, ALT 168 U/L, Alk P 2679 U/L] and dilation of biliary tract on ultrasound, resolving over several months; not likely due to amphotericin). 11229863
Johnson PC, Wheat LJ, Cloud GA, Goldman M, Lancaster D, Bamberger DM, Powderly WG, et al.; U.S. National Institute of Allergy and Infectious Diseases Mycoses Study Group. Safety and efficacy of liposomal amphotericin B compared with conventional amphotericin B for induction therapy of histoplasmosis in patients with AIDS. Ann Intern Med 2002; 137: 105-9. (Randomized trial in 81 patients with AIDS and histoplasmosis; efficacy better [88% vs 64%] and both nephrotoxicity [9% vs 37%] and liver test elevations were less frequent with the liposomal formulation vs standard forms of amphotericin [27% vs 45%]). 12118965
Inselmann G, Inselmann U, Heidemann. Amphotericin B and liver function. Eur J Intern Med 2002; 13: 288-92. (Review of mechanism of action and hepatic metabolism of amphotericin, focusing on CYP 450 effects which tend to be delayed). 12144907
Mohan U, Bush A. Amphotericin B-induced hepatorenal failure in cystic fibrosis. Ped Pulmonol 2002; 33: 497-500. (9 year old girl with cystic fibrosis became critically ill while on amphotericin B [bilirubin 0.6 mg/dL, ALT 364 U/L, Alk P 1254 or ~3 times baseline, prothrombin time 27.5 sec], with rapid reversal on stopping amphotericin B, but with other possible causes of liver injury present: Case 2). 12001285
Bowden R, Chandrasekar P, White MH, Li X, Pietrelli L, Gurwith M, van Burik JA, et al. A double-blind, randomized, controlled trial of amphotericin B colloidal dispersion versus amphotericin B for treatment of invasive aspergillosis in immunocompromised patients. Clin Infect Dis 2002; 35: 359-66. (Controlled trial in 174 patients with aspergillosis found similar efficacy, but less nephrotoxicity [25% vs 49%] and bilirubin elevations [4.5% vs 10.5% ], with colloidal dispersion formulation compared to standard forms of amphotericin). 12145716
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 6 were attributed to ketoconazole and 1 to itraconazole, but none to amphotericin). 15390328
Fischer MA, Winkelmayer WC, Rubin RH, Avorn J. The hepatotoxicity of antifungal medications in bone marrow transplant recipients. Clin Infect Dis 2005; 41: 301-7. (Among 438 patients undergoing bone marrow transplantation, 123 developed ALT or AST above 3 times ULN; factors associated with significant increases were liposomal amphotericin [Odds Ratio=3.8] and fluconazole [2.6], but not standard amphotericin [2.0]). 16007524
Wingard J, Leather H. Hepatotoxicity associated with antifungal therapy after bone marrow transplantation. Clin Infect Dis 2005; 41: 308-10. (Editorial in response to the article by Fisher [2005] discusses the difficulties of detection, diagnosis, attribution and management of liver test abnormalities after bone marrow transplantation). 16007525
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; ALT elevations occur in 3-19% of patients receiving various formulations of amphotericin: liposomal, lipid, colloid and standard; individual case report of more serious hepatotoxicity). 15751740
Cruciani M, Mengoli C, Malena M, Bosco O, Serpelloni G, Grossi P. Antifungal prophylaxis in liver transplant patients: a systematic review and meta-analysis. Liver Transpl 2006; 12: 850-8. (Metaanalysis found 6 studies with total of 698 patients comparing fluconazole, itraconazole or amphotericin vs placebo for prevention of fungal infections after liver transplantation; side effects were more with prophylaxis but liver toxicity was not discussed). 16628697
Girois SB, Chapuis F, Decullier E, Revol BG. Adverse effects of antifungal therapies in invasive fungal infections: review and meta-analysis. Eur J Clin Microbiol Infect Dis 2006; 25: 138-49. (Systematic review of adverse effects of antifungal therapy in 54 studies with 9228 patients; hepatotoxicity reported in 14.1-18.6% on amphotericin, 1.9% on fluconazole and 31.6% on itraconazole; however, great variation in definitions and intensity of monitoring). 16622909
Olin JL, Spooner LM. Amphotericin B-associated hyperbilirubinemia: case report and review of the literature. Pharmacotherapy 2006; 26: 1011-7. (53 year old with lung cancer developed marked increases in direct and total bilirubin [5.5 and 6.1 mg/dL] within 2 days of starting amphotericin with minimal increase in ALT or Alk P, resolving with stopping and recurring with rechallenge using a different formulation). 16878370
Chamilos G, Luna M, Lewis RE, Chemaly R, Raad II, Kontoyiannis DP. Effects of liposomal amphotericin B versus an amphotericin B lipid complex on liver histopathology in patients with hematologic malignancies and invasive fungal infections: a retrospective, nonrandomized autopsy study. Clin Ther 2007; 29: 1980-6. (Among 64 patients undergoing autopsy after death from cancer and fungal infections, 92% had abnormal liver tests, but histological features of hepatotoxicity were infrequent and mild, consisting of focal fatty change and necrosis). 18035197
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antifungal agents, including 4 to terbinafine, 2 to fluconazole, 1 each to ketaconazole and itraconazole, but none to linked to amphotericin therapy). 18955056
Akyol Erikci A, Ozyurt M, Terekeci H, Ozturk A, Karabudak O, Oncu K. Oesophageal aspergillosis in a case of acute lymphoblastic leukaemia successfully treated with caspofungin alone due to liposomal amphotericin B induced severe hepatotoxicity. Mycoses 2009; 52: 84-6. (18 year old man with acute lymphoblastic leukemia, treated with liposomal amphotericin B for esophageal aspergillosis, developed jaundice [bilirubin 25.1 mg/dL, ALT 914 U/L, Alk P 219 U/L], which improved upon stopping).18498301
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; mentions that nephrotoxicity is the most common dose limiting side effect of amphotericin and that liver toxicity has occurred rarely with the lipid formulations). 19940816
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials in more than 8000 patients, found liver enzyme elevations in 14.5% of patients on amphotericin, but only 0.2-1.2% stopped therapy for this reason [pooled estimates]). 20308378
Patel GP, Crank CW, Leikin JB. An evaluation of hepatotoxicity and nephrotoxicity of liposomal amphotericin B (L-AMB). J Med Toxicol 2011; 7: 12-5. (Among 75 patients treated with liposomal amphotericin B, 15 [21%] developed ALT or AST elevations >3 times ULN or bilirubin >1.5 mg/dL; but no details given). 21057910
Hamill RJ. Amphotericin B formulations: a comparative review of efficacy and toxicity. Drugs 2013; 73: 919-34. (Extensive review of the relative safety of newer formulations of amphotericin, lipid-associated preparations having less renal toxicity and fewer infusion reactions than standard deoxycholate formulations; hepatotoxicity is not discussed). 23729001
Michot JM, Gubavu C, Fourn E, Maigne G, Teicher E, Angoulvant A, Blanche S, et al. Very prolonged liposomal amphotericin B use leading to a lysosomal storage disease. Int J Antimicrob Agents 2014; 43: 566-9. (28 year old man with chronic granulomatous disease developed hepatosplenomegaly having been treated with liposomal amphotericin for 8 years [bilirubin 0.9 mg/dL, ALT 26 U/L, Alk P 698 U/L], liver biopsy showing nodular regenerative hyperplasia and sea-blue foamy macrophages [also found in the bone marrow], suggestive of lysosomal accumulation of lipid from the amphotericin liposomes). 24787480
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, 6 were attributed to antifungal agents but none to amphotericin). 24552865
Giannella M, Ercolani G, Cristini F, Morelli M, Bartoletti M, Bertuzzo V, Tedeschi S, et al. High-dose weekly liposomal amphotericin b antifungal prophylaxis in patients undergoing liver transplantation: a prospective phase II trial. Transplantation 2015; 99: 848-54. (Among 76 liver transplant recipients treated with weekly infusions of liposomal amphotericin B for at least 2 weeks, none were reported as developing worsening liver disease or clinically apparent liver injury). 25531982
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 were attributed to antifungal agents, but none to amphotericin). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Amphotericin B: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Amphotericin+B)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Amphotericin B: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Amphotericin)